# Doravirine

## OVERVIEW

### Introduction

Doravirine is a nonnucleoside reverse transcriptase inhibitor used in combination with other antiretroviral agents in the therapy of human immunodeficiency virus (HIV) infection. Doravirine is associated with a low rate of transient serum aminotransferase elevations during therapy but has not been implicated in cases of clinically apparent acute liver injury.

### Background

Doravirine (dor" a vir' een) is an antiretroviral agent that acts by noncompetitive binding to, and inhibition of, the HIV reverse transcriptase. Doravirine is a nonnucleoside reverse transcriptase inhibitor similar in action to nevirapine, efavirenz, delavirdine, etravirine and rilpivirine. In several randomized controlled trials, doravirine was found to have similar efficacy to efavirenz when combined with at least two nucleoside analogues (typically tenofovir and emtricitabine or lamivudine). Doravirine was the sixth nonnucleoside reverse transcriptase inhibitor approved by the FDA [2018], and current indications are for the treatment of HIV infection in combination with other HIV medications. Doravirine is available under the brand name Pifeltro in tablets of 100 mg. The recommended dose is 100 mg orally once daily. Doravirine is also available in a fixed dose (100 mg), oral once-a-day combination with lamivudine (300 mg) and tenofovir disoproxil fumarate (300 mg) under the brand name Delstrigo [2018]. Antiviral resistance can occur and resistance patterns are similar to, but somewhat less frequent than, those due to other nonnucleoside reverse transcriptase inhibitors. Common side effects include fatigue, dizziness, headache, diarrhea, nausea, disturbed sleep, abnormal dreams and skin rashes. Uncommon, but potentially severe adverse events include hypersensitivity reactions and immune reconstitution syndrome.

### Hepatotoxicity

Serum aminotransferase elevations were reported in 13% of patients on doravirine therapy, but elevations above 5 times the upper limit of normal were uncommon, occurring in 1% or less of patients. The rate of serum aminotransferase elevations during doravirine therapy was higher in patients who were coinfected with hepatitis B or C, but the abnormalities were rarely severe. Doravirine has been in clinical use for a short time only, but unlike many other nonnucleoside reverse transcriptase inhibitors, doravirine has yet to be linked to reported instances of clinically apparent liver injury.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

Clinically apparent hepatotoxicity from doravirine has not been reported, but liver injury from other nonnucleoside reverse transcriptase inhibitors appears to be due to hypersensitivity. Doravirine is extensively metabolized in the liver via the cytochrome P450 system (predominantly CYP 3A4) and is susceptible to drug-drug interactions with modulators of CYP 3A4. Its use with strong CYP 3A4 inducers should be avoided because of potential decreases in doravirine plasma concentrations.

### Outcome and Management

Doravirine therapy has been linked to mild and self-limited serum aminotransferase elevations which rarely require dose modification or discontinuation. Doravirine has not been linked to cases of acute hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between doravirine and other nonnucleoside reverse transcriptase inhibitors, although there may be cross reactivity in occurrence of rash.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nonnucleoside Reverse Transcriptase Inhibitors: Delavirdine, Efavirenz, Etravirine, Nevirapine, Rilpivirine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Doravirine – Pifeltro®

Doravirine, Lamivudine, Tenofovir disoproxil fumarate – Delstrigo®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Doravirine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Doravirine | 1338225-97-0 | C17-H11-Cl-F3-N5-O3 | Doravirine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents, but does not include a discussion of doravirine).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-48. (Textbook of pharmacology and therapeutics).
http://aidsinfo.nih.gov/guidelines/ (Regularly updated clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Torti C, Lapadula G, Casari S, Puoti M, Nelson M, Quiros-Roldan E, Bella D, et al.; EPOKA-MASTER Study Group. Incidence and risk factors for liver enzyme elevation during highly active antiretroviral therapy in HIV-HCV co-infected patients: results from the Italian EPOKA-MASTER Cohort. BMC Infect Dis 2005; 5: 58. (Among 1038 HIV-HCV coinfected patients starting antiretroviral therapy, the risk of ALT elevations above 5 times ULN was 17.1% yearly in treatment-naïve and 8.2% in treatment-experienced patients, risk factors being baseline ALT levels and use of nonnucleoside reverse transcriptase inhibitors). 16018804
Labarga P, Soriano V, Vispo ME, Pinilla J, Martin-Carbonero L, Castellares C, Casado R, et al. Hepatotoxicity of antiretroviral drugs is reduced after successful treatment of chronic hepatitis C in HIV-infected patients. J Infect Dis 2007; 196: 670-6. (Among 133 patients with HIV-HCV coinfection who were treated with interferon or peginterferon, 33% had a sustained response and subsequent yearly rate of hepatic events was higher among nonresponders [12.9%] than responders [3.1%]; also more common with dideoxynucleosides). 17674307
Rivero A, Mira JA, Pineda JA. Liver toxicity induced by non-nucleoside reverse transcriptase inhibitors. J Antimicrob Chemother 2007; 59: 342-6. (Review of liver toxicity of nevirapine and efavirenz, ALT elevations >5 times ULN reported in 1-8% of efavirenz compared to 4-16% of nevirapine recipients; no mention of delavirdine or rilpivirine). 17255142
Soriano V, Puoti M, Garcia-Gascó Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. Antiretroviral drugs and liver injury. AIDS 2008; 22: 1-13. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes; problematic agents include didanosine, stavudine and zidovudine, nevirapine and efavirenz, full dose ritonavir and tipranavir). 18090386
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiretroviral agent, but none to rilpivirine or doravirine). 25754159
Colombier MA, Molina JM. Doravirine: a review. Curr Opin HIV AIDS 2018; 13: 308-14. (Review of the structure, mechanism of action, pharmacology, drug-drug interactions, antiviral resistance patterns, clinical efficacy and safety of doravirine; no specific discussion of ALT elevations or hepatotoxicity). 29794817
Molina JM, Squires K, Sax PE, Cahn P, Lombaard J, DeJesus E, Lai MT, et al.; DRIVE-FORWARD Study Group. Doravirine versus ritonavir-boosted darunavir in antiretroviral-naive adults with HIV-1 (DRIVE-FORWARD): 48-week results of a randomised, double-blind, phase 3, non-inferiority trial. Lancet HIV 2018; 5: e211-e220. (Among 769 HIV infected patients treated with doravirine vs darunavir/R combined with 2 antiretroviral nucleoside analogues, rates of HIV RNA suppression were similar [84% vs 80%], and common side effects included diarrhea, nausea and headache, ALT elevations above 5 times ULN occurring in 1% vs 2% and not requiring discontinuation in any doravirine-treated subject). 29592840
Orkin C, Squires KE, Molina JM, Sax PE, Wong WW, Sussmann O, Kaplan R, et al.; DRIVE-AHEAD Study Group. Doravirine/lamivudine/tenofovir disoproxil fumarate is non-inferior to efavirenz/emtricitabine/tenofovir disoproxil fumarate in treatment-naive adults with human immunodeficiency virus-1 infection: week 48 results of the DRIVE-AHEAD trial. Clin Infect Dis 2019; 68: 535-44. (Among 728 HIV infected patients treated with doravirine vs efavirenz [both combined with 2 antiretroviral nucleoside analogues], rates of viral suppression were similar [84% vs 81%] while adverse events were less with doravirine including drug-related adverse events [31% vs 63%], serious adverse events [4% vs 6%], rash [5% vs 12%] and ALT elevations above 5 times ULN [0.6% vs 1.4%]). 30184165
Deeks ED. Doravirine: first global approval. Drugs 2018; 78: 1643-50. (Review of the structure, pharmacology, clinical efficacy, resistance patterns, and safety of doravirine shortly after its approval for use in the US; does not mention ALT elevations or hepatotoxicity). 30341683

## OTHER REFERENCE LINKS

1. Recent References on Doravirine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Doravirine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Doravirine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Doravirine)